# Ketamine

## OVERVIEW

### Introduction

Ketamine is a parenterally administered, general anesthetic used largely for short term diagnostic and surgical procedures, but which has been limited in use because of its psychological side effects including vivid hallucinations, agitation and confusion. Ketamine also has major abuse potential and is used illicitly as a recreational drug. Long term ketamine use can cause inflammation and irritation to the urinary bladder and urethra, and similar changes have recently been described in the biliary tract, resulting in an acute or chronic cholestatic liver injury that can resemble sclerosing cholangitis.

### Background

Ketamine (kee' ta meen) is an arylcyclohexylamine anesthetic that acts as a noncompetitive inhibitor of N-methyl-D-apartate (NMDA) receptors in the brain. Ketamine infusions rapidly produce anesthesia and a unique cataleptic state with profound analgesia, amnesia and unresponsiveness, but often with maintenance of muscle tone, involuntary movements, open eyes and spontaneous breathing. The effect is called dissociative anesthesia, which can be associated with vivid hallucinations, agitation and delirium during emergence. These adverse effects of ketamine are less in children, but have limited its usefulness as a routine anesthetic agent in adults. The lack of severe respiratory depression and relative maintenance of cardiac function with ketamine anesthesia has made it useful in patients with high risk of bronchospasm or hypotension. Ketamine was approved for use in the United States in 1970. Current indications are as the sole anesthetic agent for short term diagnostic and surgical procedures, for induction of anesthesia prior to other general anesthetic agents, and as an adjunct to low potency agents. Ketamine is available as liquid solution for intramuscular or intravenous injection in vials of 50 mg/mL in several generic forms and under the brand name of Ketalar. Ketamine is also used experimentally as therapy of severe forms of chronic pain for which it is given chronically or intermittently. Because of its profound neuropsychiatric effects, ketamine has become a recreational drug of abuse (“Special K”) in which it is used as a powder orally or by inhalation in doses that cause hallucinations and dissociative feelings. Ketamine has unique psychological side effects including dissociative states, hallucinations and emergence delirium that can occur in 12% of recipients and can arise up to 24 hours after anesthesia. Ketamine is also associated with elevation in blood pressure and pulse, variable effects on respiration (stimulation, suppression), increase in intraocular pressure and, with chronic use, severe irritative and inflammatory urinary tract and bladder symptoms.

### Hepatotoxicity

Short term use of ketamine for anesthesia has been associated with rare instances of serum enzyme elevations, but not with clinically apparent liver injury. With chronic or intermittent use, however, unusual biliary and hepatic complications have been described. In a manner similar to its effects on the urinary tract, ketamine can also cause abnormalities in the biliary system with dilation and irregularity of the intra- and extra-hepatic bile ducts. Patients typically developed right upper quadrant pain and tenderness associated with elevations in serum alkaline phosphatase and aminotransferase levels, with minimal or no increase in bilirubin (Case 1). Biliary imaging may reveal dilation and irregularity of the intra- and extra-hepatic bile ducts with fusiform dilation of the common bile duct suggestive of choledochal cysts. Liver biopsy demonstrates changes suggestive of chronic liver obstruction or sclerosing cholangitis. Discontinuation of ketamine is usually followed by slow improvement and the abnormalities found on biliary imaging may no longer be demonstrable several months later.

Likelihood score: B (highly likely cause of clinically apparent biliary and hepatic injury).

### Mechanism of Injury

The mechanism by which ketamine causes urinary and biliary abnormalities is not known, but the high concentrations of ketamine metabolites in urine and bile may cause direct toxic injury to surface epithelium with repeated use. Ketamine undergoes extensive hepatic metabolism, largely via the cytochrome P450 system (CYP 3A4). The hepatobiliary injury might be due to a direct effect of ketamine or to a toxic intermediate of its metabolism on the biliary epithelial cell.

### Outcome and Management

Clinically apparent hepatobiliary injury associated with ketamine arises during chronic rather than acute exposure, and is most commonly associated with ketamine abuse or experimental applications as in the therapy of chronic pain syndromes. Most patients improve once ketamine is stopped and no instances of cirrhosis or hepatic failure from ketamine use have been described. Patients may require intensive abuse counseling and management.

Drug Class: Anesthetics, General

## CASE REPORT

### Case 1. Sclerosing cholangitis due to recreational ketamine use.

[Modified from: Turkish A, Luo JJ, Lefkowitch JH. Ketamine abuse, biliary tract disease, and secondary sclerosing cholangitis. Hepatology 2013, 58: 825-7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/23695896)]

A 21 year old man who had been using ketamine recreationally developed fever, abdominal pain and abnormal liver tests. He had been inhaling ketamine daily for at least 9 months and had developed recurrent acute renal failure and bilateral hydronephrosis. He also admitted to alcohol binges, but denied injection drug use or a history of acute hepatitis. Liver tests showed a total bilirubin of 0.7 mg/dL, ALT 257 U/L, AST 276 U/L, alkaline phosphatase 384 U/L and GGT 985 U/L (normal <59). Liver tests had also been abnormal when he was admitted for episodes of acute renal failure and then pyelonephritis 6 and 2 months previously, which were attributed to ketamine abuse (Table). Tests for hepatitis A, B and C were negative as were tests for Wilson disease and autoantibodies. Ultrasound showed an echogenic liver with normal portal vein blood flow, and abdominal computerized tomography showed no hepatic or bile duct abnormalities. He was treated with antibiotics for suspected pyelonephritis and improved. Two months later, however, he was readmitted with recurrent symptoms and renal abnormalities and was again found to have elevations in ALT and alkaline phosphatase. A liver biopsy showed concentric fibrosis around intrahepatic bile ducts, with bile duct proliferation and mild portal inflammatory changes suggestive of sclerosing cholangitis. He was enrolled in a drug rehabilitation program and liver tests improved, although alkaline phosphatase levels remained slightly elevated. In follow up, magnetic resonance cholangiopancreatography (MRCP) revealed normal intra- and extra-hepatic bile ducts without dilation or narrowing.

#### Key Points

Medication: | Ketamine (by inhalation daily for 9 months)
Pattern: | Cholestatic (R=1.2)
Severity: | 1+ (liver enzyme elevations without jaundice)
Latency: | 9 months
Recovery: | Partial upon stopping ketamine
Other medications: | None mentioned

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
3 months | Pre | 116 | 590 | 1.2 | Acute renal failure
9 months | Pre | 836 | 292 | 0.5 | Pyelonephritis
10 months | Pre | 175 | 483 | 0.5 | Outpatient visit
11 months | 0 | 257 | 384 | 0.7 | Readmission
11.3 months | 1 week | 260 | 537 | 0.2
12 months | 4 weeks | 300 | 438 | 0.2 | Liver biopsy
19 months | 8 months | 44 | 214 | 0.5 | Outpatient
Normal Values | | <42 | <130 | <1.2

#### Comment

A young man with a history of inhalation ketamine abuse developed recurrent bouts of cystitis and pyelonephritis and was found to have evidence of hepatobiliary disease. Liver tests suggested a chronic cholestatic pattern of injury, but CT and MRCP imaging were unremarkable. A liver biopsy showed changes typical of sclerosing cholangitis or chronic biliary obstruction. Thus, the normal MRCP did not rule out this form of biliary sclerosis that can affect both large and small bile ducts.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ketamine – Generic, Ketalar®

DRUG CLASS

Anesthetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ketamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ketamine | 6740-88-1 | C13-H16-Cl-N-O | Ketamine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 April 2018

Zimmerman HJ. Anesthetic agents. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 457-82. (Expert review of hepatotoxicity of anesthetic agents published in 1999; ketamine is not discussed).
Kenna JG. Mechanism, pathology, and clinical presentation of hepatoxicity of anesthetic agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 403-22. (Review of liver injury from anesthetic agents does not discuss ketamine).
Patel PM, Patel HH, Roth DM. Ketamine. General anesthetics and therapeutic gases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 538-9. (Textbook of pharmacology and therapeutics).
Wolff K, Winstock AR. Ketamine: from medicine to misuse. CNS Drugs 2006; 20: 199-218. (Review of the mechanism of action, pharmacology and the medical, research and recreational uses of ketamine with summary of adverse events focusing largely on psychological reactions, cognitive decline, flashbacks and social withdrawal). 16529526
Storr TM, Quibell R. Can ketamine prescribed for pain cause damage to the urinary tract? Palliat Med 2009; 23: 670-2. (Description of 3 patients who developed urologic symptoms [pain, hematuria, dysuria, frequency] and structural abnormalities [contracted bladder, cystitis, inflammatory changes] while receiving oral ketamine for chronic pain, with symptoms resolving upon stopping). 19648225
Wong SW, Lee KF, Wong J, Ng WW, Cheung YS, Lai PB. Dilated common bile ducts mimicking choledochal cysts in ketamine abusers. Hong Kong Med J 2009; 15: 53-6. (2 men and one woman, ages 21-27 years, who had been abusing ketamine for 1-7 years had recurrent epigastric pain with mildly abnormal liver tests [bilirubin normal, ALT 75-333 U/L, Alk P 122-137 U/L], and fusiform dilations of the common bile duct, occasionally with strictures, somewhat resembling choledochal cysts). 19197097
Lo RS, Krishnamoorthy R, Freeman JG, Austin AS. Cholestasis and biliary dilatation associated with chronic ketamine abuse: a case series. Singapore Med J 2011; 52: e52-5. (3 men, ages 26-27, abusing ketamine for 2-9 years, developed recurrent bouts of right upper quadrant pain with abnormal liver tests [bilirubin 0.2-3.4 mg/dL, ALT 75-482 U/L, Alk P 178-2475 U/L] and biliary abnormalities, including common bile duct dilation and gall bladder dyskinesia and contraction). 21451916
Seto WK, Ng M, Chan P, Ng IO, Cheung SC, Hung IF, Yuen MF, Lai CL. Ketamine-induced cholangiopathy: a case report. Am J Gastroenterol 2011; 106: 1004-5. (32 year old woman developed recurrent epigastric pain having abused ketamine for 7 years [bilirubin and ALT "relatively normal", Alk P 229 U/L], ERCP showing long segment strictures and liver biopsy showing nonspecific inflammation around portal tracts). 21540907
Wood D, Cottrell A, Baker SC, Southgate J, Harris M, Fulford S, Woodhouse C, Gillatt D. Recreational ketamine: from pleasure to pain. BJU Int 2011; 107: 1881-4. (Review of the recently recognized clinical syndrome of urologic injury from ketamine abuse characterized by pain, frequency, dysuria, and incontinence and painful bladder that can lead to a small contracted bladder, upper tract obstruction, hydronephrosis and papillary necrosis, probably caused by direct toxicity to the bladder and urethral epithelium). 21314885
Noppers IM, Niesters M, Aarts LP, Bauer MC, Drewes AM, Dahan A, Sarton EY. Drug-induced liver injury following a repeated course of ketamine treatment for chronic pain in CRPS type 1 patients: a report of 3 cases. Pain 2011; 152: 2173-8. (Three of 6 patients with chronic pain treated with 100 hour infusions of ketamine every 4 weeks developed liver test abnormalities before or during the second course of treatment [peak ALT 77-593 U/L, Alk P normal to 240 U/L], which resolved upon stopping). 21546160
Sear JW. Ketamine hepato-toxicity in chronic pain management: another example of unexpected toxicity or a predicted result from previous clinical and pre-clinical data? Pain 2011; 152: 1946-7. (Editorial accompanying Noppers [2011]). 21555186
Westerling D, Lindblom P. Re: Noppers et al., Drug-induced liver injury following a reported course of ketamine treatment for chronic pain in CRPS type I patients. A report on 3 cases. Pain 2012; 153: 502; author reply 502-3. (Letter in response to Noppers [2011] questioning the dosage of ketamine used). 22154331
Turkish A, Luo JJ, Lekfowitch JH. Ketamine abuse, biliary tract disease and secondary sclerosing cholangitis. Hepatology 2013; 58: 825-7. (21 year old man abusing ketamine by inhalation developed recurrent pyelonephritis and liver test abnormalities [bilirubin 0.7 mg/dL, ALT 257 U/L, Alk P 384 U/L], improving but not resolving completely upon rehabilitation from ketamine abuse: Case 1). 23695896
Zhou J, Shaw SG, Gilleece Y. Dilated common bile duct and deranged liver function tests associated with ketamine use in two HIV-positive MSM. Int J STD AIDS 2013; 24: 667-9. (Two cases, 38 and 25 year old men with HIV infection on antiretroviral therapy developed epigastric pain and nausea and were found to have abnormal liver tests while using ketamine regularly [bilirubin normal, ALT 131 and 418 U/L, Alk P 215 and 315 U/L], with mild duct dilatation shown by MRI [18 and 14 mm], with resolution of symptoms, liver test abnormalities and bile duct dilatation on stopping ketamine use). 23970577
Wong GL, Tam YH, Ng CF, Chan AW, Choi PC, Chu WC, Lai PB et al. Liver injury is common among chronic abusers of ketamine. Clin Gastroenterol Hepatol 2014; 12: 1759-62.e1. (Among 297 patients with chronic ketamine abuse, 29 had liver test abnormalities [mean ALT 251 U/L, Alk P 289 U/L, R ratio 1.5, bilirubin not given], liver biopsy showing biliary injury resembling PSC and fibrosis in 3, while imaging showed fusiform dilatation of the common bile duct in 3). 24534547
Yu WL, Cho CC, Lung PF, Hung EH, Hui JW, Chau HH, Chan AW, et al. Ketamine-related cholangiopathy: a retrospective study on clinical and imaging findings. Abdom Imaging 2014; 39: 1241-6. (Among 26 patients with chronic ketamine use who had undergone CT or MRCP imaging of the liver, 18 [69%] had fusiform dilation of the common bile duct without intrahepatic dilation or evidence of gallstones or filling defects, the abnormalities subsequently improving with abstinence). 24934474
Pappachan JM, Raj B, Thomas S, Hanna FW. Multiorgan dysfunction related to chronic ketamine abuse. Proc (Bayl Univ Med Cent) 2014; 27: 223-5. (59 year old man who inhaled ketamine daily for 3 years developed weight loss, anorexia and urologic symptoms and was found to have hydronephrosis, common bile duct dilatation and jaundice [bilirubin 2.0 mg/dL, ALT 46 U/L, Alk P 970 U/L, albumin 2.3 g/dL], which improved on stopping ketamine use and all liver tests were normal 2 months later). 24982568
Bevan R, Burke D. Ketamine as a possible cause of cirrhosis in a patient with chronic pain. Frontline Gastroenterol 2014; 5: 208-10. (55 year old woman on ketamine for chronic pain for 10 years, developed abnormal liver tests [bilirubin 0.5 mg/dL, ALT 188 U/L, Alk P 228 U/L] and liver biopsy showed bridging fibrosis, but imaging showed no irregularities; no follow up information provided). 28839772
Yee CH, Teoh JY, Lai PT, Leung VY, Chu WC, Lee WM, Tam YH, et al. The risk of upper urinary tract involvement in patients with ketamine-associated uropathy. Int Neurourol J 2017; 21(2): 128-32. (Among 572 patients with ketamine uropathy seen between 2011 and 2015, 17% had hydronephrosis and "deranged" serum liver enzymes were present in 60% with hydronephrosis and 42% without; no mention of bilirubin elevations or clinically apparent liver injury). 28673061

## OTHER REFERENCE LINKS

1. Recent References on Ketamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ketamine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ketamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ketamine)